# Cephalosporins, Oral

## OVERVIEW

### Introduction

The orally available cephalosporins are widely used as broad spectrum antibiotics for mild-to-moderate infections with susceptible organisms. Despite their widescale use, cases of drug induced liver disease from the cephalosporins are very rare, with only isolated case reports having been published.

### Background

The oral cephalosporins are available in both generic and trade formulations and include cefaclor (Ceclor, Raniclor: 2nd), cefadroxil (Duracef: 1st), cefdinir (Omnicef: 3rd), cefditoren (Spectracef: 3rd), cefixime (Suprax: 3rd), cefpodoxime (Vantin: 3rd), cefprozil (Cefzil: 2nd), ceftibuten (Cedax: 3rd), cephalexin (Keftab: Apo-Cephalex, Biocef, Keflex, NovoLexin, Nu-Cephalex: 1st), cefuroxime (Ceftin: 2nd), cephradine (Velosef: 1st), and loracarbef (Lorabid: 2nd). Cefuroxime and cephradine are also available in parenteral forms. The typical dose regimens for oral cephalosporins are 250 to 500 mg two to four times daily for 7 to 14 days. The oral cephalosporins are widely used in medicine for mild-to-moderate infections due to susceptible bacteria. The oral cephalosporins are generally well tolerated; adverse events can include diarrhea, nausea, abdominal pain, dyspepsia, headache, and rash. Rare but potentially severe adverse events include Clostridium difficile-associated diarrhea, hypersensitivity reactions, angioedema, anaphylaxis and Stevens Johnson syndrome/toxic epidermal necrolysis.

### Hepatotoxicity

Oral cephalosporins can be associated with minor elevations in serum aminotransferase and alkaline phosphatase values, but these are generally mild, transient and not associated with symptoms or development of more severe liver injury. The frequency of these elevations is reported to be as high as 11%, but varies depending upon the frequency of monitoring, duration of therapy, and nature and severity of the underlying illness. Clinically apparent liver injury from oral cephalosporin use is rare, only isolated case reports having been published, and not all of the formulations have been linked to cases of liver injury. The clinical pattern of injury suggests that hepatotoxicity is largely a class effect from the cephalosporins, even though it is idiosyncratic and rare. The typical latency period has been 1 to 4 weeks with an abrupt onset of liver injury. The pattern of serum enzyme elevations is usually cholestatic, but mixed and hepatocellular instances have been reported. Liver injury is often accompanied by fever, rash and eosinophilia or other signs and symptoms of hypersensitivity. A history of penicillin allergy is not common.

Likelihood score: B (cephalosporins as a class are very likely but rare causes of clinically apparent liver injury, the association having been made largely with the most frequently used agents, such as cefazolin, cephalexin and ceftriaxone).

### Mechanism of Injury

The mechanism of hepatic injury due to cephalosporins is unknown, but believed to be hypersensitivity and similar to that of other penicillins.

### Outcome and Management

In most case reports, recovery has been rapid within 4 to 8 weeks without residual injury or persistent serum enzyme elevations. Among the few cases reported, none have been fatal. It is unclear whether there is cross sensitivity to the hepatic injury induced by cephalosporins. In many published cases, patients have been switched to an alternative cephalosporin without recurrence of injury, but it is more judicious to switch to another class of agents. Similarly, patients with a history of penicillin allergy have a higher rate of hypersensitivity reactions to cephalosporins, and they should be avoided or started with careful supervision and monitoring.

References to oral cephalosporin induced liver injury are provided in the introductory overview chapter on Cephalosporins.

Drug Class: Antiinfective Agents, Cephalosporins

## CASE REPORT

### Case 1. Cholestatic hepatitis related to cefuroxime.(1)

A 52 year old man was given a 10-day course of oral cefuroxime for recurrent folliculitis, but developed worsening skin rash and itching, and was found to be jaundiced 7 weeks after starting the antibiotic. Laboratory testing showed prominent elevations in serum AST and alkaline phosphatase with a total bilirubin of 8.4 mg/dL (Table). Tests for autoantibodies and for serologic evidence of hepatitis A, B and C were negative. Imaging tests of the liver including ultrasound, MRI and MRCP were unremarkable. The patient had a complex past medical history of diabetes, hypertension, coronary artery disease, chronic back pain and asthma for which he took several medications chronically, none of which had been changed recently. He abused alcohol for many years, but had abstained for 4 years. He had no known allergies. His cholestasis and liver disease were prolonged, and ultimately he underwent liver biopsy which showed changes of chronic inflammation and intrahepatic cholestasis compatible with drug induced liver disease. The diagnosis of cephalosporin induced liver injury had not been fully appreciated and he received two 10-day courses of cephalexin during this period of jaundice. These exposures were not associated with appreciable changes in serum enzyme levels, but were followed by an increase in serum bilirubin levels and skin rash (Table). Because of persistent pruritus, he was treated with ursodiol, cholestyramine and several antihistaminics. Ultimately, his rash and itching resolved; serum bilirubin fell to normal, but there were minor elevations in ALT and alkaline phosphatase that did not fall into the completely normal range for more than a year after the initial presentation.

#### Key Points

Medication: | Cefuroxime, 500 mg daily for 10 days
Pattern: | Cholestatic (R=1.2)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 6 weeks
Recovery: | More than 6 months
Other medications: | Fluticasone and salmeterol inhalant and albuterol (for asthma), insulin (diabetes), gabapentin (neuropathy), lisinopril and hydrochlorothiazide (hypertension), cyclobenzaprine and the combination of hydrocodone and acetaminophen (low back pain)

#### Laboratory Values

Time after Starting | Time after Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comment
Ten day course of cefuroxime: weeks 1-2
8 weeks | 6 weeks | 268 | 651 | 8.4 | Jaundice and pruritus
9 weeks | 8 weeks | 264 | 595 | 7.1
Two courses of cephalexin: weeks 10-14
15 weeks | 14 weeks | 284 | 720 | 11.8
Five day course of cefuroxime: week 19
20 weeks | 19 weeks | 189 | 812 | 4.7 | Erythema
21 weeks | 20 weeks | 191 | 859 | 3.6
22 weeks | 21 weeks | 176 | 717 | 2.1 | Pruritus
6 months | 6 months | 111 | 428 | 1.0
7 months | 7 months | 69 | 174 | 0.7
8 months | 8 months | 74 | 217 | 1.0 | Asymptomatic
15 months | 15 months | 42 | 169 | 0.7
18 months | 18 months | 32 | 131 | 0.4
20 months | 20 months | 35 | 119 | 0.4
Normal Values | | <35 | <130 | <1.2

#### Comment

The prolonged course of cholestasis with no obvious cause was most likely due to drug induced liver injury, and cefuroxime (a third generation, orally available cephalosporin) was the most likely cause. The long incubation period is unusual for cephalosporin related liver injury. Furthermore, rechallenge with cephalexin and then with cefuroxime appeared to worsen the course minimally, if at all, but may have been the reason for the delayed recovery. A year after the initial presentation, the patient was without symptoms, but serum enzymes were still mildly abnormal. Ultimately, however, even these mild biochemical abnormalities resolved.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cefuroxime – Generic, Ceftin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=cefuroxime)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Cefuroxime | 55268-75-2 | C16-H16-N4-O8-S

## CITED REFERENCES

1 Alqahtani SA, Kleiner DE, Ghabril M, Gu J, Hoofnagle JH, Rockey DC, Drug-Induced Liver Injury Network (DILIN) Study Investigators. (2015). Identification and characterization of cefazolin-induced liver injury. Clin Gastroenterol Hepatol.

## NOTE

References to both the oral and parenteral cephalosporins as well as review articles on the relative frequency of cephalosporin-related liver injury are given in the overview chapter on Cephalosporins.